# Pretomanid

## OVERVIEW

### Introduction

Pretomanid is a nitroimidazooxazine antimycobacterial agent used in combination with other antituberculosis drugs in the treatment of multidrug resistant tuberculosis. The addition of pretomanid to antituberculosis drug regimens has been linked to an increased rate of transient serum liver test abnormalities during treatment and to several instances of mild, clinically apparent liver injury.

### Background

Pretomanid (pre toe’ ma nid) is a unique antimycobacterial agent that has activity against multidrug resistant mycobacterium tuberculosis both in vitro and in vivo and was first approved for use in the United States in 2019. A nitroimidazooxazine, pretomanid is believed to act via inhibition of mycolic acid synthesis, blocking mycobacterial cell wall synthesis. Its current indications are for multidrug resistant pulmonary tuberculosis in combination with other antituberculosis agents. It is not approved for use in latent or drug sensitive tuberculosis or in atypical mycobacterial infections. In addition, pretomanid has not been shown to be effective for extra-pulmonary tuberculosis. Pretomanid is available in tablets of 200 mg under the brand name Pretomanid. The recommended dose is 200 mg once daily in combination with bedaquiline and linezolid for 26 weeks. Side effects of this regimen are common and include peripheral neuropathy, acne, anemia, nausea, vomiting, dyspepsia, anorexia, weight loss, diarrhea, abdominal pain, headache, rash, pruritus, cough, pleuritic pain, hemoptysis, back pain, visual impairment and hypoglycemia. Laboratory abnormalities include anemia and increases in serum aminotransferase levels and amylase. Rare, but potentially serious adverse reactions include myelosuppression, peripheral and optic neuropathy, prolongation of the QTc interval, lactic acidosis and reproductive effects including impaired fertility.

The management of multidrug resistant tuberculosis is challenging and should be under the direction of physicians with expertise in tuberculosis therapy and management of its side effects. Optimal regimens of therapy for tuberculosis are complex and change frequently. Regularly updated recommendations on use of pretomanid and other drugs for tuberculosis, including indications, contraindications, warnings, dosages and monitoring recommendations are available at the Centers for Disease Control and Prevention website: http://www.cdc.gov/tb/publications/guidelines/Treatment.htm.

### Hepatotoxicity

Liver test abnormalities occur in 30% of patients treated with multiple drug regimens that include pretomanid. These abnormalities are usually asymptomatic, mild-to-moderate in severity and self-limited in duration. In many instances, it is difficult to determine which of the antituberculosis medications account for the abnormalities, but regular monitoring of liver tests is recommended during triple therapy with pretomanid, bedaquiline and linezolid. Clinically apparent liver injury has been reported with pretomanid-based therapies, but largely in regimens that included moxifloxacin or pyrazinamide or both. The clinical features, course and outcome of these cases has not been well defined. In the pivotal study of pretomanid combined with bedaquiline and linezolid in 109 adults with drug resistant pulmonary tuberculosis, 12 patients (11%) developed ALT levels above 3 times the upper limit of normal (ULN) of whom two also developed mild jaundice (bilirubin above twice but less than 3 times ULN) arising during month two of therapy. Both patients had mild nausea accompanying the liver test abnormalities, and the abnormalities resolved in both with temporary interruption in treatment, followed by re-initiation using lower dose linezolid without change in the pretomanid dose. In this pivotal trial, most adverse events were attributed to linezolid.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which pretomanid might cause serum aminotransferase elevations or clinically apparent liver injury is not known but is likely due to production of a toxic intermediate during its metabolism. Pretomanid is metabolized by the liver via multiple reductive and oxidative pathways, the P450 system (predominantly CPY 3A4) accounting for approximately 20% of its metabolism. Nevertheless, pretomanid is susceptible to drug-drug interactions with agents that induce or inhibit CYP3A4 and with substrates of the organic anion transporter 3 (OAT-3) which also participates it is metabolism and excretion.

### Outcome and Management

Patients on pretomanid should be monitored with liver tests, including serum bilirubin, ALT, AST and alkaline phosphatase before starting therapy and at intervals thereafter. Pretomanid should be discontinued for persistent increases in liver test abnormalities, ALT elevations accompanied by increases in total bilirubin of more than twice normal or by any symptom or sign of liver injury. There is no evidence to suggest cross sensitivity to liver injury or adverse events between pretomanid and other antituberculosis medications.

Drug Class: [underlined: Antituberculosis Agents] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/AntituberculosisAgen/)

Other Drugs in the Class: Bedaquline (https://www.ncbi.nlm.nih.gov/books/NBK548859/), Capreomycin (https://www.ncbi.nlm.nih.gov/books/NBK548641/), [underlined: Cycloserine] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Cycloserine/), [underlined: Ethambutol] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Ethambutol/), [underlined: Ethionamide] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Ethionamide/), [underlined: Isoniazid] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Isoniazid/), [underlined: Pyrazinamide] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Pyrazinamide/), [underlined: Rifabutin] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Rifabutin/), [underlined: Rifampin] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Rifampin/), [underlined: Rifapentine] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Rifapentine/), [underlined: Streptomycin] (https://preview.ncbi.nlm.nih.gov/books/prevqa/n/livertox/Streptomycin/)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pretomanid – Pretomanid®

DRUG CLASS

Antituberculosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=af277d80-ac01-4aaf-87b8-86a152a7f323)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pretomanid | 187235-37-6 (https://pubchem.ncbi.nlm.nih.gov/substance/135143585) | C14-H12-F3-N3-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 04 November 2019

Zimmerman HJ. Antituberculosis agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antituberculosis medications published in 1999 before the availability of pretomanid).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs published before the availability of bedaquiline or pretomanid).
Gumba T. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1549-70. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212862Orig1s000OtherR.pdf (FDA website with review of safety and efficacy of pretomanid includes specific analysis of its potential hepatotoxicity [pages 31-49]).
Ginsberg AM, Laurenzi MW, Rouse DJ, Whitney KD, Spigelman MK. (2009). Safety, tolerability, and pharmacokinetics of PA-824 in healthy subjects. Antimicrob Agents Chemother. (Among 58 healthy volunteers dose once daily with pretomanid [15 to 1500 mg] once daily for up to 7 days, there were “no significant or serious adverse events”; no mention of ALT or AST elevations).
Diacon AH, Dawson R, du Bois J, Narunsky K, Venter A, Donald PR, van Niekerk C, et al. (2012). Phase II dose-ranging trial of the early bactericidal activity of PA-824. Antimicrob Agents Chemother. (Among 69 South African adults with pulmonary tuberculosis enrolled in a dose-ranging 14-day study, response rates were similar with 100 and 200 mg daily and there were no drug related serious adverse events; no mention of ALT or AST elevations).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to pretomanid).
Diacon AH, Donald PR, Pym A, Grobusch M, Patientia RF, Mahanyele R, Bantubani N, et al. (2012). Randomized pilot trial of eight weeks of bedaquiline (TMC207) treatment for multidrug-resistant tuberculosis: long-term outcome, tolerability, and effect on emergence of drug resistance. Antimicrob Agents Chemother. (47 patients with multidrug resistant tuberculosis were treated with bedaquiline or placebo with background regimens for up to 6 months; major side effects not mentioned).
Roehr B. (2012). Trial tests new combination of drugs to treat tuberculosis. BMJ. (News report that the Global Alliance for TB Drug Development had launched a trial of pretomanid [PA 824], a new drug candidate for drug resistant tuberculosis).
Centers for Disease Control and Prevention. (2013). Provisional CDC guidelines for the use and safety monitoring of bedaquiline fumarate (Sirturo) for the treatment of multidrug-resistant tuberculosis. MMWR Recomm Rep. (Recommendations on use of bedaquiline mentions that patients should be monitored monthly and bedaquiline should be discontinued for persistent ALT or AST elevations, concurrent elevations of serum bilirubin, ALT or AST elevations above 8 times the ULN, or any liver test abnormalities accompanied by symptoms of liver injury).
Dooley KE, Luetkemeyer AF, Park JG, Allen R, Cramer Y, Murray S, Sutherland D, et al. (2014). AIDS Clinical Trials Group A5306 Study Team. Phase I safety, pharmacokinetics, and pharmacogenetics study of the antituberculosis drug PA-824 with concomitant lopinavir-ritonavir, efavirenz, or rifampin. Antimicrob Agents Chemother. (Study of pharmacokinetics of pretomanid when combined with various antiretroviral agents demonstrated that maximal plasma levels were reduced when combined with efavirenz [-28%] or rifampin [-53%], but reductions were less [-13%] when combined with lopinavir-ritonavir).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 408 were attributed to antimicrobial agents including 52 to antituberculosis agents, but no cases were attributed to pretomanid or bedaquiline).
Dawson R, Diacon AH, Everitt D, van Niekerk C, Donald PR, Burger DA, Schall R, et al. (2015). Efficiency and safety of the combination of moxifloxacin, pretomanid (PA-824), and pyrazinamide during the first 8 weeks of antituberculosis treatment: a phase 2b, open-label, partly randomised trial in patients with drug-susceptible or drug-resistant pulmonary tuberculosis. Lancet. (Among 207 adults with pulmonary tuberculosis treated with standard therapy or pretomanid in combination with moxifloxacin and pyrazinamide for 8 weeks, antimycobacterial activity was similar with all regimens and pretomanid regimens had excellent activity against multidrug resistant infections, while adverse event rates were similar including ALT or AST elevations above 3 times ULN [12%, 17% and 18% in the 3 pretomanid arms vs 12% in controls]).
Dheda K, Gumbo T, Maartens G, Dooley KE, Murray M, Furin J, Nardell EA, et al. (2019). Lancet Respiratory Medicine drug-resistant tuberculosis Commission group. The Lancet Respiratory Medicine Commission: 2019 update: epidemiology, pathogenesis, transmission, diagnosis, and management of multidrug-resistant and incurable tuberculosis. Lancet Respir Med. (Review of the epidemiology, pathogenesis, diagnosis and management of multidrug resistant tuberculosis; does not discuss hepatotoxicity of therapeutic drug regimens).
Keam SJ. (2019). Pretomanid: First Approval. Drugs. (Summary of the US FDA approval of pretomanid combined with bedaquiline and linezolid as therapy of multidrug resistant tuberculosis for 26 weeks; mentions that common adverse events noted in the 109 patients treated in registration trials included peripheral neuropathy [81%], acne [39%], anemia [37%], nausea [37%], vomiting [34%], myalgia [29%], headache [28%], increased aminotransferase [28%] and GGT levels [17%], dyspepsia [24%], anorexia [22%], rash [21%], pruritus [20%] and abdominal pain [19%], but there were no liver related serious adverse events or deaths).

## OTHER REFERENCE LINKS

1 Recent References on Pretomanid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/pubmed?cmd=search&pubmedfilters=true&term=(Pretomanid%2FAE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice%2FCI+OR+bile+duct+diseases%2FCI+OR+liver%2FDE+OR+liver+diseases%2FCI)+AND+(%221900%2F1%2F1%22%5BEDat%5D%3A%222999%2F12%2F31%22%5BEDat%5D))
2 Trials on Pretomanid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pretomanid)